# Copper

## OVERVIEW

### Introduction

Copper is an essential trace element that is included in some over-the-counter multivitamin and mineral supplements, even though copper deficiency is quite rare and supplementation is rarely needed. The amounts of copper found in typical supplements has not been associated with serum enzyme elevations or with clinically apparent liver injury. However, accidental or intentional copper overdose can cause an acute liver injury and chronic ingestion of excessive amounts of copper can result in copper overload and chronic liver injury.

### Background

Copper is a heavy metal and essential trace element that is found in many human enzymes and transcription factors. The recommended dietary allowance is approximately 1.5 mg per day. Adequate amounts of copper are found in most Western diets, with highest levels found in shellfish, chocolate and nuts. Total body copper concentrations are 50 to 120 mg (0.79 to 1.9 mmol), which is far lower than those of zinc or iron. Copper deficiency is rare and usually due to malnutrition and reduced dietary intake, but can also occur with strict vegetarian diets. Chronic oral exposure to excessive amounts of copper can result in liver injury which is also typical of Wilson disease, an inherited disease caused by a mutation in the ATPase7B gene, which encodes a hepatic enzyme responsible for the transmembrane transport and excretion of copper. The metabolic defect in Wilson disease leads to accumulation of free copper in liver and blood and secondarily in other organs, particularly brain and kidney. The disease usually presents in childhood or adolescence with neurologic syndromes, signs of advanced liver disease and hemolytic anemia. Excessive dietary intake or environmental exposure to copper is rare in the developed world, but is found in developing countries and particularly India. Nutritional supplements with copper generally have replacement doses of copper and available in many forms. Elemental copper for oral intake is not available in United States.

### Hepatotoxicity

Acute hepatotoxicity of copper is usually the result of ingestion of toxic amounts (1 to 10 g), often as a suicide attempt. In children, accidental poisoning can occur, particularly with ingestion of coins. Initial symptoms may be metallic taste and gastrointestinal distress due to gastric or small bowel erosions. Acute overdoses of copper can lead to early appearance of cardiovascular collapse, coma and death within hours. Liver injury tends to arise after 24 to 72 hours and is characterized by marked elevations in serum aminotransferase levels, minimal increases in alkaline phosphatase, early appearance of hepatic failure, and elevation in prothrombin time and ensuing jaundice. Shock and renal failure may also be present as well as rhabdomyolysis and severe hemolytic anemia. The overall clinical pattern of the liver injury is that of acute hepatic necrosis, and the hepatic manifestations resemble the acute toxicity of iron and zinc, and can be reproduced in animals. Shock and rhabdomyolysis may contribute to the serum enzyme elevations while hemolytic anemia may account for some of the increase in total bilirubin levels. Therapy of copper overdose includes gastric lavage, fluid replacement, dimercaprol (BAL) and penicillamine, with blood transfusions for hemolytic anemia and dialysis for acute renal failure.

Chronic liver injury from copper occurs with Wilson disease, but has also been described after chronic excessive ingestion of copper and perhaps as a result of chronic environmental exposure, such as from copper tubing used in hemodialysis.

Likelihood score: A[HD] (well known cause of acute and chronic liver injury but only when taken in high doses).

Drug Class: Trace Elements and Metals

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Copper Sulfate – Generic

DRUG CLASS

Trace Elements and Metals

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=copper)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Cupric Sulfate | 7758-98-7 | Cu.H2-O4-S | Chemical Structure for Copper

## ANNOTATED BIBLIOGRAPHY

References updated: 30 October 2017

Zimmerman HJ. Copper poisoning. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, p 347. (Review of hepatotoxicity published in 1999 mentions that copper hepatotoxicity may be acute or chronic, the acute poisoning resembling iron hepatotoxicity, the chronic injury leading to cirrhosis and possibly being the cause of Indian childhood cirrhosis).
Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Textbook on hepatotoxicity; the acute hepatotoxicity of copper is not discussed).
Byrns MC, Penning TM. Treatment of metal exposure. Environmental toxicology: carcinogens and heavy metals. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1872 -6. (Textbook of pharmacology and therapeutics).
Turnlund JR. Copper. In, Shils ME, Olson JA, Shihe M, Ross AC, eds. Modern Nutrition in Health and Disease. 9th ed. Baltimore: Williams & Wilkins, 1999, pp. 241-252. (Textbook of nutrition).
Semple AB, Parry WH, Phillips DE. Acute copper poisoning. An outbreak traced to contaminated water from a corroded geyser. Lancet 1960; 2 (7152): 700-1. (18 workers in a factory developed gastroenteritis after drinking tea from a single teapot contaminated with copper caused by corrosion of copper pipes; no clinical details given). 13750037
Chowdhury AK, Ghosh S, Pal D. Acute copper sulphate poisoning. J Indian Med Assoc 1961; 36: 330-6. (Review of 20 cases of acute copper poisoning, marked by metallic taste, epigastric pain and nausea followed by vomiting, tachycardia, hypotension and jaundice [50%] and/or hemolysis [50%]). 13693318
Gupta PS, Bhargava SP, Sharma ML. Acute copper sulphate poisoning with special reference to its management with corticosteroid therapy. J Assoc Physicians India 1962; 10: 287-92. (Review of 150 cases of copper poisoning seen at a single hospital in New Delhi over a 5 year period treated with gastric lavage, dimercaprol [BAL], fluids, transfusions, sedatives and corticosteroids; patient ages 13 to 60 years, 102 cases were mild and 48 severe; jaundice arising in 19%, circulatory collapse in 7% and death in 24 [16%]). 13903000
Wahl PK, Lahiri B, Mathur KS, Kehar U, Wahi PN. Acute copper sulphate poisoning. J Assoc Physicians India 1963; 11: 93-103. (Review of 50 cases of copper poisoning admitted over a 2 year period to a single hospital in India, treated with gastric lavage, dimercaprol [BAL] and fluids, 17 patients [34%] developing jaundice, arising between days 2 and 5, ALT ranging from 30 to 150 U/L and autopsy in 7 showing focal necrosis and fatty change in the liver). 13998300
Chuttani HK, Gupta PS, Gulati S, Gupta DN. Acute copper sulfate poisoning. Am J Med 1965; 39: 849-54. (Description of 53 patients with acute copper poisoning, ages 14 to 60 years, 32 men and 21 women, usually with suicidal intent, presenting with metallic taste, nausea, vomiting and epigastric burning, jaundice arising in 23%, usually on days 2 or 3, leading to death in some or resolving in 2-5 days, liver showing centrilobular necrosis and cholestasis). 5833579
Fairbanks VF. Copper sulfate-induced hemolytic anemia. Inhibition of glucose-6-phosphate dehydrogenase and other possible etiologic mechanisms. Arch Intern Med 1967; 120: 428-32. (22 year old woman had accidental ingestion of copper sulfate and developed nausea, vomiting and diarrhea for 2 days followed by dark urine and hemolysis [hematocrit falling to 20%], with slow recovery; all liver tests were normal). 4293707
Singh MM, Singh G. Biochemical changes in blood in cases of acute copper sulphate poisoning. J Indian Med Assoc 1968; 50: 549-54. (Among 40 patients with acute copper poisoning, 27 were men, 13 women, ages 13 to 85 years, AST levels ranged from 36-3400 U/L, ALT 66-440 U/L, bilirubin 0.4-30 mg/dL [most less than 2.0 mg/dL] and 4 patients died, one of hepatic failure and three from hemolysis). 5708633
Deodhar LP, Deshpande CK. Acute copper sulphate poisoning. J Postgrad Med 1968; 14: 38-41. (Seven autopsied cases of acute copper intoxication, included 5 who died within hours of presentation and 2 on day 5 with jaundice [bilirubin 7.0 and 7.7 mg/dL] and "cloudy and fatty degeneration of liver cells", with focal and centrilobular necrosis). 5648509
Papadoyanakis N, Katsilambros N, Patsourakos B. Acute copper sulfate poisoning with jaundice. J Ir Med Assoc 1969; 62: 99-100. (36 year old man took and overdose of copper sulfate and was admitted in coma three hours later and developed hemolytic anemia and jaundice the following day [bilirubin rising to 6.6 mg/dL, AST 190 U/L], dying 11 days after ingestion and autopsy showing cholestasis and inflammation, but "necrosis was not seen"). 5776964
Manzler AD, Schreiner AW. Copper-induced acute hemolytic anemia. A new complication of hemodialysis. Ann Intern Med 1970; 73: 409-12. (3 men developed copper intoxication during hemodialysis with acute onset of nausea, diarrhea and lethargy and acute hemolysis; no mention of liver test abnormalities). 5455992
Chugh KS, Singhal PC, Sharma BK. Letter: Methemoglobinemia in acute copper sulfate poisoning. Ann Intern Med 1975; 82: 226-7. (27 year old man took an overdose of copper sulfate which led to vomiting and lethargy followed by cyanosis, oliguria, methemoglobinemia, intravascular hemolysis, shock and death 16 hours after the ingestion). 1115446
Klein WJ Jr, Metz EN, Price AR. Acute copper intoxication. A hazard of hemodialysis. Arch Intern Med 1972; 129: 578-82. (Hemodialysis using copper tubing can result in significant copper exposure; 3 adults, ages 35 to 53 years, developed headache, myalgias, fatigue, diarrhea and nausea during hemodialysis with severe hemolytic anemia, metabolic acidosis, high serum copper levels, progressive coma and death, sometimes with minor AST and bilirubin elevations). 5019446
Agarwal BN, Bray SH, Bercz P, Plotzker R, Labovitz E. Ineffectiveness of hemodialysis in copper sulphate poisoning. Nephron 1975; 15: 74-7. (41 year old woman took an overdose of copper sulfate developing vomiting and diarrhea, and was treated with fluids, EDTA, gastric lavage and hemodialysis, but had progressive hemolysis and liver and renal failure [bilirubin 0.6 mg initially rising to 20.6 mg/dL, AST to >6000 U/L, Alk P 139 U/L, LDH 8,500 U/L, CPK 4,100 U/L], dying after 5 days). 1128758
Stein RS, Jenkins D, Korns ME. Letter: Death after use of cupric sulfate as emetic. JAMA 1976; 235: 801. (44 year old woman with a three-quarter gastrectomy was given cupric sulfate as an emetic after an overdose of diazepam and developed lethargy and hypotension one hour later, followed by severe hemolytic anemia, respiratory, hepatic and renal failure, dying 6 days later). 946302
Walsh FM, Crosson FJ, Bayley M, McReynolds J, Pearson BJ. Acute copper intoxication. Pathophysiology and therapy with a case report. Am J Dis Child 1977; 131: 149-51. (18 month old boy drank a copper sulfate solution and developed nausea, vomiting and lethargy, high serum copper [1,650 μg/dL] and hemolysis, responding to dimercaprol [BAL] treatment with resolution within one week, liver tests remaining normal). 835530
Chugh KS, Sharma BK, Singhal PC, Das KC, Datta BN. Acute renal failure following copper sulphate intoxication. Postgrad Med J 1977; 53: 18-23. (Among 29 patients with acute copper poisoning admitted to a referral hospital in India over a 10 year period, 11 [38%] presented with acute renal failure, usually after 3-8 days [creatinine 2.5-14.5 mg/dL] and liver injury [27%] [bilirubin 1.5-14.5 mg/dL, serum copper 115-8269 µg/dL, hemoglobin 2-9 g/dL]). 876909
Chugh KS, Sakhuja V. Acute copper intoxication. Int J Artif Organs 1979; 2: 181-2. (Brief review of the clinical manifestations and management of acute copper intoxication). 457302
Sternlieb I. Copper and the liver. Gastroenterology 1980; 78: 1615-28. (Review of the metabolism of copper and its role in Wilson disease). 6245986
Schwartz E, Schmidt E. Refractory shock secondary to copper sulfate ingestion. Ann Emerg Med 1986; 15: 952-4. (62 year old man took an overdose of copper sulfate and developed nausea, vomiting and stupor with persistent hypotension followed by severe hemolytic anemia and elevated liver enzymes and death, no details of liver tests provided). 3740585
Yelin G, Taff ML, Sadowski GE. Copper toxicity following massive ingestion of coins. Am J Forensic Med Pathol 1987; 8: 78-85. (58 year old woman with severe neuropsychiatric disability, developed nausea, weight loss, jaundice and stupor [bilirubin 11.7 mg/dL, direct bilirubin 7.0 mg/dL, ALT 53 U/L, Alk P 2.2 U/L, pH 6.86, lactate 30.9 mg/dL, hemoglobin 4.6 g/dL, reticulocyte count >20%] and died in coma 38 hours later, autopsy showing 275 coins in stomach and liver with fat, Mallory bodies, fibrosis and excess copper). 3578211
Mueller PD, Benowitz NL. Toxicologic causes of acute abdominal disorders. Emerg Med Clin North Am 1989; 7: 667-82. (Review of gastrointestinal toxicity of agents including iron, mercury and copper). 2663462
Hantson P, Lievens M, Mahieu P. Accidental ingestion of a zinc and copper sulfate preparation. J Toxicol Clin Toxicol 1996; 34: 725-30. (86 year old woman inadvertently drank a zinc and copper sulfate solution, rapidly developed vomiting and watery diarrhea [copper 209 µg/dL, normal <140: zinc 1979 µg/dL, normal <123], was treated with gastric lavage, hydration, penicillamine and dimercaprol [BAL], but developed hypotension, respiratory and renal failure, while liver tests remained normal; she ultimately recovered). 8941204
Strubelt O, Kremer J, Tilse A, Keogh J, Pentz R, Younes M. Comparative studies on the toxicity of mercury, cadmium, and copper toward the isolated perfused rat liver. J Toxicol Environ Health 1996; 47: 267-83. (Comparison of toxicity of equimolar amounts of mercury, cadmium and copper in an isolated, perfused rat liver system found similar patterns of toxicity which appeared to be mitochondrial with reductions in ATP levels). 8604150
Bennett DR, Baird CJ, Chan KM, Crookes PF, Bremner CG, Gottlieb MM, Naritoku WY. Zinc toxicity following massive coin ingestion. Am J Forensic Med Pathol 1997; 18: 148-53. (55 year old man with schizophrenia developed nausea, anorexia, epigastric pain and gastrointestinal bleeding, and ultimately was found to have 461 coins in the stomach which were removed surgically, but he developed renal and hepatic failure [peak bilirubin 12.2 mg/dL, ALT 341 U/L, AST 1141 U/L], autopsy showing massive hepatic and acute tubular necrosis). 9185931
Rodeck B, Kardoff R, Melter M. Treatment of copper associated liver disease in childhood. Eur J Med Res 1999; 4: 253-6. (Two German children, ages 6 and 10 months, developed abdominal swelling and ascites [bilirubin 3.0 and 8.8 mg/dL, ALT 325 and 170 U/L, GGT 140 U/L], high copper levels found in liver and in well water, one improved with penicillamine therapy, but the second required liver transplantation). 10383883
Takeda T, Yukioka T, Shimazaki S. Cupric sulfate intoxication with rhabdomyolysis, treated with chelating agents and blood purification. Intern Med 2000; 39: 253-5. (18 year old man took an overdose of cupric sulfate and developed vomiting and lethargy [serum copper 142 µg/dL, normal <131], was treated with gastric lavage, penicillamine and dimercaprol [BAL], but developed myoglobinemia, hemolysis and rhabdomyolysis [peak CK 3,804 U/L on day 6] with mild renal and liver injury, ultimately resolving after 18 days). 10772131
Dietrich AM, Glindemann D, Pizarro F, Gidi V, Olivares M, Araya M, Camper A, et al. Health and aesthetic impacts of copper corrosion on drinking water. Water Sci Technol 2004; 49(2): 55-62. (Corrosion of copper pipes can cause excess copper in the water supply that is associated with metallic taste and increase in gastrointestinal illness). 14982164
Srivastava A, Peshin SS, Kaleekal T, Gupta SK. An epidemiological study of poisoning cases reported to the National Poisons Information Centre, All India Institute of Medical Sciences, New Delhi. Hum Exp Toxicol 2005; 24: 279-85. (Among 2719 calls to an Indian poisoning center over a 3 year period, 48 [2%] were concerning copper sulfate). 16004194
Donoso A, Cruces P, Camacho J, Rí JC, Paris E, Mieres JJ. Acute respiratory distress syndrome resulting from inhalation of powdered copper. Clin Toxicol (Phila) 2007; 45: 714-6. (2 year old girl spilled copper powder on her face and inhaled some of the contents, developing cough, dyspnea and cyanosis and, on admission, had hypoxia and acidosis, developing respiratory and renal failure and evidence of liver injury over the next several days [AST 105 U/L, ammonia 120 µmol/L, prothrombin index 20%], but ultimately recovered). 17849249
Franchitto N, Gandia-Mailly P, Georges B, Galinier A, Telmon N, DucasséL, Rougé. Acute copper sulphate poisoning: a case report and literature review. Resuscitation 2008; 78: 92-6. (29 year old man developed vomiting and diarrhea shortly after taking overdose of copper sulfate [homemade rat poison], with fever and acute psychosis, initially with normal liver and renal tests, developing mild hemolytic anemia and renal dysfunction, treated with EDTA and dimercaprol [BAL], and resolving within 1 week). 18482790
Hassan S, Shaikh MU, Ali N, Riaz M. Copper sulphate toxicity in a young male complicated by methemoglobinemia, rhabdomyolysis and renal failure. J Coll Physicians Surg Pak 2010; 20 (7): 490-1. (22 year old man accidentally drank a cup of copper sulfate and developed severe vomiting, abdominal pain and dehydration, treated with gastric lavage, penicillamine and dimercaprol [BAL], with increase in methemoglobinemia, acute renal failure, liver dysfunction [bilirubin 2.9 mg/dL, ALT 85 U/L, Alk P 30 U/L] and adult respiratory distress syndrome, eventually improving and resolving within 2 weeks). 20642956
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to ingestion of copper). 20949552
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: 2396-404. (Among 313 cases of drug induced liver injury seen between 1997 and 2008 at a large hospital in Bangalore, India, none were attributed to copper ingestion or copper overdoses). 20648003
Valsami S, Stamoulis K, Lydataki E, Fountoulaki-Paparizos L. Acute copper sulphate poisoning: a forgotten cause of severe intravascular haemolysis. Br J Haematol 2012; 156: 294. (25 year old man presented 18 hours after overdose with copper sulfate with hemolytic anemia [hematocrit initially 44% falling to 25% in 3 days], with rhabdomyolysis and mild renal and liver impairment). 21981599
Naha K, Saravu K, Shastry BA. Blue vitriol poisoning: a 10-year experience in a tertiary care hospital. Clin Toxicol (Phila) 2012; 50: 197-201. (Among 35 cases of acute copper poisoning presenting at a single referral center in Southern India over a 10 year period, the average age was 29 years, symptoms included vomiting [85%], diarrhea [46%], epigastric pain [43%], blood in stool [31%), hematuria [26%], burning chest pain [17%] and jaundice [37%] and 8 patients died). 22372787
Weiss KH, Stremmel W. Evolving perspectives in Wilson disease diagnosis: treatment and monitoring. Curr Gastroenterol Rep 2012; 14: 1-7. (Review of the diagnosis and management of Wilson disease, including the role of genetic testing and the choice of medical therapies). 22083169
Rifkin J, Miller MD. Copper-associated hepatitis in a Pembroke Welsh corgi. Can Vet J 2014; 55: 573-6. (6 year old Welsh corgi developed poor appetite and weight loss and was found to have liver injury [bilirubin not given, ALT 1366 U/L, Alk P 201 U/L], laparotomy showing an abnormal looking liver with fatty change, fibrosis and excessive copper, later responding to penicillamine, ursodiol andS-adenosylvmethionine with normalization of ALT levels). 24891642
Breuer C, Oh J, Nolkemper D, Achilles EG, Fischer L, Eglite I, Guesmer C, et al. Successful detoxification and liver transplantation in a severe poisoning with a chemical wood preservative containing chromium, copper, and arsenic. Transplantation 2015; 99: e29-30. (4 year old boy ingested wood preservative with chromated copper arsenate and rapidly developed abdominal pain and vomiting followed by acute liver and kidney failure treated with dialysis, BAL and liver transplantation 5 days later; liver showing "toxic liver damage"). 25827325
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none of the cases were attributed to copper ingestion). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Copper: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Copper/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Copper: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Copper)